# Cat's Claw

## OVERVIEW

### Introduction

Cat's claw is an herbal medicine derived from the bark of the Uncaria tomentosa vine which is used for its antiinflammatory and immune modulating effects in the treatment of fever, fatigue, muscle and joint aches and the symptoms of chronic inflammatory conditions. Cat’s claw has not been implicated in causing liver injury.

### Background

Cat's claw is a large vine that grows in the Amazon River basin and has been used in South American traditional medicine for centuries, its name referring to the curved thorns found along its woody vines that resemble cats’ claws. Cat's claw includes two species, Uncaria tomentosa and Uncaria guinaensis, and the extract is usually made from their root bark most commonly from U. tomentosa. Cat's claw is used as an analgesic and antiinflammatory agent to treat gastrointestinal, rheumatologic and other chronic inflammatory conditions. Constituents of cat’s claw extracts include oxindole alkaloids (isopteropodine, pteropodine, rhynchophylline, mytraphylline, speciophylline, uncarine F, uncarine E), indole alkaloidal glucosides (cadambine, 3-dihydrocadambine, and 3-isodihydrocadambine), quinovic acid glycosides, tannins, polyphenols, catechins and beta sitosterol. In vitro, extracts of cat’s claw have immune modulatory, antiviral and antimutagenic activities. The active ingredients of cat’s claw extracts are not completely well defined. Studies in cell culture have shown that the oxindole alkaloids decrease TNF alpha levels by inhibition of NF-kappa B signaling, a finding that has been claimed to be the biologic basis for its antiinflammatory activity. On the other hand, the polyphenols and catechins found in the bark also have antioxidant actions. In humans, the evidence for efficacy of cat’s claw extracts has been mixed. While small controlled trials have suggested a beneficial effect on pain in chronic rheumatoid and osteoarthritis, other studies have been inconclusive, the improvements in clinical symptoms being similar to those with placebo or comparator arms. Nevertheless, cat’s claw is widely used and claimed to have antiinflammatory and analgesic effects and is given often in combination with other nutritional supplements (such as glucosamine and chondroitin) or with conventional therapies. The usual doses used vary by preparation, from 30 to 300 mg of extract once daily. Side effects of orally administered cat’s claw are minor and may include nausea, gastrointestinal upset and diarrhea.

### Hepatotoxicity

Despite being widely used, cat's claw has not been implicated in cases of clinically apparent liver injury and, in prospective studies, has had no effect on serum enzyme levels. In vitro studies have demonstrated antioxidant activity of cat’s claw extracts which may be hepatoprotective. Because cat’s claw inhibits microsomal CYP 3A4 activity, it has a potential to cause herb-drug interactions and raise the levels of other drugs that are metabolized by CYP 3A4.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

Other Names: Uña de Gato, Hawk's Claw

Drug Class: Herbal and Dietary Supplements

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Cat's Claw – Generic

DRUG CLASS

Herbal and Dietary Supplements

COMPLETE LABELING

Fact Sheet at National Center for Complementary and Integrative Health (https://nccih.nih.gov/health/catclaw)

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Cat's Claw | C300000000 | Herbal Mixture | Not applicable

## ANNOTATED BIBLIOGRAPHY

References updated: 18 February 2019

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; cat's claw is not discussed).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of herbal and dietary supplements [HDS]; cat's claw is not discussed).
Cat’s claw. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp. 319-20. (Compilation of short monographs on herbal medications and dietary supplements).
Sandoval M, Charbonnet RM, Okuhama NN, Roberts J, Krenova Z, Trentacosti AM, Miller MJ. Cat's claw inhibits TNF alpha production and scavenges free radicals: role in cytoprotection. Free Radic Biol Med 2000; 29: 71-8. (In vitro studies of cat's claw demonstrated inhibition of free radical generation and TNF alpha production in response to lipopolysaccharide as well as antioxidant effects but at higher levels, suggesting that the antiinflammatory effects of cat's claw are due to inhibition of free radical generation). 10962207
Piscoya J, Rodriguez Z, Bustamante SA, Okuhama NN, Miller MJ, Sandoval M. Efficacy and safety of freeze-dried cat's claw in osteoarthritis of the knee: mechanisms of action of the species Uncaria guianensis. Inflamm Res 2001; 50: 442-8. (Among 45 patients with painful osteoarthritis of the knee treated with cat's claw [100 mg once daily] or placebo for 4 weeks, pain scores decreased more with cat's claw, but night time pain and swelling did not change; cat's claw was well tolerated and there were no serious adverse events or changes in serum ALT and AST values during treatment). 11603848
Mur E, Hartig F, Eibl G, Schirmer M. Randomized double-blind trial of an extract from the pentacyclic alkaloid-chemotype of uncaria tomentosa for the treatment of rheumatoid arthritis. J Rheumatol 2002; 29: 678-81. (In a randomized trial of cat's claw [30 mg daily] vs placebo in 40 patients with rheumatoid arthritis, adverse events were uncommon and minor, the most common being dyspepsia and pruritus; laboratory results did not change). 11950006
Miller MJ, Mehta K, Kunte S, Raut V, Gala J, Dhumale R, Shukla A, et al. Early relief of osteoarthritis symptoms with a natural mineral supplement and a herbomineral combination: a randomized controlled trial [ISRCTN38432711]. J Inflamm (Lond) 2005; 2: 11. (Among 107 patients with osteoarthritis of the knee who were treated with low or high doses of a multimineral supplement alone or low doses combined with cat's claw or placebo for 8 weeks, pain, stiffness and physical function scores improved in all groups, none significantly greater than with placebo, while all were well tolerated with no serious adverse events and no changes in serum creatinine or ALT levels during treatment). 16242032
Valerio LG Jr, Gonzales GF. Toxicological aspects of the South American herbs cat's claw (Uncaria tomentosa) and Maca (Lepidium meyenii): a critical synopsis. Toxicol Rev 2005; 24 (1): 11-35. (Extensive review of the pharmacological and toxicological features of two popular South American traditional remedies, maca and cat's claw, the latter having some evidence for analgesic but little for antiinflammatory activity in humans, but appears to have no serious toxicity when used orally; ALT elevations and hepatotoxicity are not mentioned). 16042502
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, et al.; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, 9% were attributed to herbals or dietary supplements, but none were thought to be due to cat's claw). 19132805
Erowele GI, Kalejaiye AO. Pharmacology and therapeutic uses of cat's claw. Am J Health Syst Pharm 2009; 66: 992-5. (Critical review of the mechanisms of action, clinical efficacy and safety of cat's claw concludes that there is little evidence for its efficacy in treating arthritis or inflammatory conditions, and although generally well tolerated, it can cause drug-drug interactions, particularly with anticoagulants, and is contraindicated in pregnant and lactating mothers and recipients of organ transplants; no mention of ALT elevations during therapy or hepatotoxicity). 19451609
Akhtar N, Haqqi TM. Current nutraceuticals in the management of osteoarthritis: a review. Ther Adv Musculoskelet Dis 2012; 4: 181-207. (Review of the biologic basis, clinical efficacy and safety of herbals medications used to treat osteoarthritis including cat's claw; no mention of hepatotoxicity or ALT elevations). 22850529
Stickel F, Kessebohm K, Weimann R, Seitz HK. Review of liver injury associated with dietary supplements. Liver Int 2011; 31: 595-605. (Review of liver injury from HDS focusing upon Herbalife and Hydroxycut products, green tea, usnic acid, Noni juice, and Chinese herbs; does not mention cat's claw). 21457433
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int 2012 32: 1543-56. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs and supplements; does not list cat's claw or uncaria tomentosa). 22928722
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology 2014; 60: 1399-408. (Among 85 cases of HDS associated liver injury [not due to anabolic steroids] enrolled in a US prospective study between 2004 and 2013, none were attributed to cat's claw). 25043597
García-Cortés M, Robles-Díaz M, Ortega-Alonso A, Medina-Caliz I, Andrade RJ. Hepatotoxicity by dietary supplements: a tabular listing and clinical characteristics. Int J Mol Sci 2016; 17: 537. (Listing of published cases of liver injury from HDS products; does not mention cat's claw). 27070596
Brown AC. Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107 (Pt A): 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products; does not list cat's claw among products linked to liver injury). 27402097
Seeff LB, Bonkovsky HL, Navarro VJ, Wang G. Herbal products and the liver: a review of adverse effects and mechanisms. Gastroenterology 2015; 148: 517-32. (Extensive review of possible beneficial as well as harmful effects of herbal products on the liver; mentions that multiingredient supplements have been implicated in many cases of liver injury including proprietary agents marketed under the names Herbalife, Hydroxycut and OxyELITE Pro, but does not specifically discuss or mention cat's claw either as a single herbal product or as part of multiingredient dietary supplements). 25500423
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a prospective database between 2004 and 2012, HDS were implicated in 145 [16%], the single major herbal cause being green tea and no cases clearly implicating cat's claw). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Cat's Claw: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=cascara+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Cat's Claw: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=cascara)